# Quetiapine

## OVERVIEW

### Introduction

Quetiapine is an atypical antipsychotic used in the treatment of schizophrenia and bipolar disorder. Use of quetiapine has been associated with serum aminotransferase elevations and in rare instances with clinically apparent acute liver injury.

### Background

Quetiapine (kwe tye' a peen) is an atypical antipsychotic and dibenzodiazepine derivative which appears to act as a dopamine (D1-4) and serotonin (5-HT2) receptor antagonist. It also may have activity against histamine and alpha adrenergic receptors. Quetiapine is indicated for the treatment of schizophrenia and as either monotherapy or adjunctive therapy for acute manic episodes or as maintenance therapy in bipolar I disorder. It is also used in treatment of depressive episodes associated with bipolar I or II disorder and for major depressive disorders in combination with antidepressants. Quetiapine was approved for use in the United States in 1997 and is still widely used with more than 10 million prescriptions filled yearly in the United States. Quetiapine is available as tablets of 25, 50, 100, 200, 300 and 400 mg generically and under the brand name Seroquel. Typical doses vary from 300 to 800 mg daily given in two divided doses. Extended release forms are also available for once daily dosing. Common side effects include dizziness, sedation, somnolence, dry mouth, constipation, weakness, postural hypotension, increased appetite and weight gain. Rare, but potentially severe adverse events include neuroleptic malignant syndrome, tardive dyskinesia, severe dyslipidemia, diabetes, weight gain, hypotension, bone marrow suppression and cataracts. Quetiapine like most atypical antipsychotic agents has a boxed warning for increased risk of death in patients with dementia-related psychosis, and like most potent antidepressants it has a boxed warning for suicidal thoughts and behaviors.

### Hepatotoxicity

Liver test abnormalities may occur in up to 30% of patients on long term therapy with quetiapine, but elevations are uncommonly above 3 times the upper limit of normal. The aminotransferase abnormalities are usually mild, asymptomatic and transient, reversing even with continuation of medication. Instances of clinically apparent acute liver injury have been reported due to quetiapine, but they are rare. The onset of jaundice is within 1 to 4 weeks of starting the drug, and the pattern of serum enzyme elevations is typically hepatocellular. Signs of immunoallergic manifestations (fever, rash and eosinophilia) are rare, as are autoantibodies. Most cases are mild-to-moderate in severity and self-limited in course. Instances of DRESS syndrome and acute liver failure have been reported but not vanishing bile duct syndrome or chronic liver injury.

Likelihood score: B (likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which quetiapine causes serum aminotransferase elevations is not known, but is likely due to production of a toxic intermediate by its metabolism. Quetiapine is extensively metabolized by the liver via sulfoxidation and oxidation, partially via CYP 3A4. Some instances of serum aminotransferase elevations occurring on quetiapine therapy may be due to nonalcoholic fatty liver disease caused by weight gain that occurs in at least one-quarter of treated patients, generally during the first 1 to 2 years of therapy.

### Outcome and Management

The serum aminotransferase elevations that occur on quetiapine therapy are usually self-limited and usually do not require dose modification or discontinuation of therapy. Cases of clinically apparent liver injury are usually mild to moderate in severity and self-limited course. Rare instances of acute liver failure due to quetiapine have been reported, but it has not been implicated in cases of chronic liver disease or vanishing bile duct syndrome. Patients with quetiapine induced liver injury may have cross sensitivity to other atypical antipsychotics (risperidone) but usually tolerate switching to others.

Drug Class: Antipsychotic Agents, Atypicals

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Quetiapine – Generic, Seroquel®

DRUG CLASS

Antipsychotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Quetiapine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Quetiapine | 111974-69-7 | C21-H25-N3-O2-S

## ANNOTATED BIBLIOGRAPHY

References updated: June 6, 2023

Meyer JM. Pharmacotherapy of psychosis and mania. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 279-302. (Textbook of pharmacology and therapeutics).
(1997). Quetiapine for schizophrenia. Med Lett Drugs Ther. (Brief review of efficacy and safety of quetiapine shortly after its approval in the US; common side effects include somnolence, dizziness, constipation, postural hypotension, dry mouth and weight gain; “increases in serum aminotransferase activity have occurred in some patients”).
Allison DB, Mentore JL, Heo M, Chandler LP, Cappelleri JC, Infante MC, Weiden PJ. (1999). Antipsychotic-induced weight gain: a comprehensive research synthesis. Am J Psychiatry. (Systematic review of 81 articles on weight change with antipsychotics, using change after 10 weeks to compare agents: clozapine +5.7, olanzapine +4.2, chlorpromazine +4.2, quetiapine +2.5, risperidone +1.7, loxapine +0.6, haloperidol +0.5, ziprasidone +0.3, molindone -0.1, and pimozide -2.7 kg).
Balestrieri M, Vampini C, Bellantuono C. (2000). Efficacy and safety of novel antipsychotics: a critical review. Hum Psychopharmacol. (Review on efficacy and safety of quetiapine; “Mild, transient, reversible and asymptomatic elevations in the liver enzymes were seen in a small number of patients”).
Garver DL. (2000). Review of quetiapine side effects. J Clin Psychiatry. (Discussion of side effects [weight gain, sedation, extrapyramidal syndrome] of quetiapine based upon known profile of neuroreceptor blockade).
Mullen J, Jobson MD, Sweitzer D. (2001). A comparison of the relative safety, efficacy, and tolerability of quetiapine and risperidone in outpatients with schizophrenia and other psychotic disorders: the quetiapine experience with safety and tolerability (QUEST) study. Clin Ther. (4 month trial of quetiapine vs risperidone in 728 patients at 115 centers; no mention of ALT abnormalities or adverse events from liver injury).
Lieberman JA, Perkins DO. (2002). Quetiapine: a 5-year update. J Clin Psychiatry. (Editorial; quetiapine discovered in 1985 at AstraZeneca, approved in US for schizophrenia in 1997).
Nasrallah HA, Tandon R. (2002). Efficacy, safety, and tolerability of quetiapine in patients with schizophrenia. J Clin Psychiatry. (Review of 9 clinical trials of quetiapine in patients with schizophrenia; ALT elevations occurred but were mild and reversible; ALT levels were >3 times ULN in 6% of quetiapine- vs 1% of placebo-recipients, usually within the first 3 weeks of treatment and without hepatitis or jaundice).
(2003). Choice of an antipsychotic. Med Lett Drugs Ther. (Quetiapine, a second generation antipsychotic, is generally well tolerated; no mention of hepatic effects).
Prior TI, Baker GB. (2003). Interactions between the cytochrome P450 system and the second-generation antipsychotics. J Psychiatry Neurosci. (Review of the interactions of the atypical antipsychotics with the P450 system; clozapine metabolized by CYP1A2 and 3A4 and possibly 2C9 and 2D6; risperidone by CYP2D6 and possibly 3A4; olanzapine by CYP1A2 and possibly 2D6; quetiapine and ziprasidone by CYP3A4).
El Hajj I, Sharara AI, Rockey DC. (2004). Subfulminant liver failure associated with quetiapine. Eur J Gastroenterol Hepatol. (58 year old woman developed jaundice 1 month after starting quetiapine [bilirubin 17.3 mg/dL, ALT 1245 U/L, Alk P 265 U/L, ANA 1:2560], progressing to liver failure and death within 21 days; autopsy showed massive necrosis).
Langman LJ, Kaliciak HA, Carlyle S. (2004). Fatal overdoses associated with quetiapine. J Anal Toxicol. (Three cases of overdose with quetiapine, 39-56 year olds, found dead at home soon after overdose; respiratory arrest; no information on hepatic injury).
Rettenbacher MA, Baumgartner S, Eder-Ischia U, Edlinger M, Graziadei I, Hofer A, Huber R, et al. (2006). Association between antipsychotic-induced elevation of liver enzymes and weight gain: a prospective study. J Clin Psychopharmacol. (Prospective study of 67 patients started on atypical antipsychotics [9 on quetiapine]; ALT elevations were more frequent in 14 who gained >7% of body weight than in the 53 who did not [50% vs 19%] and mean changes in ALT, AST and GGT were greater in those who gained weight; all abnormalities were transient, asymptomatic and not associated with bilirubin elevations).
Wright TM, Vandenberg AM. (2007). Risperidone- and quetiapine-induced cholestasis. Ann Pharmacother. (30 year old man developed jaundice after being on risperidone and lithium for 8 years [bilirubin 4.7 mg/dL, ALT 99 U/L, Alk P 267 U/L], resolving with change of risperidone to ziprasidone, but 1 year later developed recurrent jaundice 3 weeks after starting quetiapine, having tolerated olanzapine).
Atasoy N, Erdogan A, Yalug I, Ozturk U, Konuk N, Atik L, Ustundag Y. (2007). A review of liver function tests during treatment with atypical antipsychotic drugs: a chart review study. Prog Neuropsychopharmacol Biol Psychiatry. (Retrospective analysis on 194 patients; ALT levels were >3 times ULN in 27% often in first month; among 48 receiving quetiapine, 27% had ALT elevations, 23% at 6 months, but they were modest and none had elevations greater than 3 fold).
Torrent C, Amann B, Sanchez-Moreno J, Colom F, Feinares M, Comes M, Rosa AR, et al. (2008). Weight gain in bipolar disorder: pharmacological treatment as a contributing factor. Acta Psychiatr Scand. (Review of frequency of weight gain in patients treated for bipolar disorders, most weight gain occurred with clozapine and olanzapine, but some weight gain also with quetiapine, risperidone, lithium, valproate and gabapentin; not with aripiprazole, ziprasidone, carbamazepine or lamotrigine).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008; several antidepressants [duloxetine, sertaline, fluoxetine, amitryptilline], but none of the atypical antipsychotic agents were implicated).
Shpaner A, Li W, Ankoma-Sey V, Botero RC. (2008). Drug-induced liver injury: hepatotoxicity of quetiapine revisited. Eur J Gastroenterol Hepatol. (21 year old man developed jaundice 10 days after starting quetiapine [bilirubin 14.7 mg/dL, ALT 2582 U/L, Alk P 167 U/L, ANA negative, prolonged INR], resolving completely with stopping).
Flanagan RJ. (2008). Fatal toxicity of drugs used in psychiatry. Hum Psychopharmacol. (Deaths from fatal poisonings decreased in England and Wales between 1993-2004; antipsychotic overdose fatalities higher for phenothiazines than atypicals; deaths/million prescriptions being 29 for chlorpromazine, 15.5 thioridazine, 3.9 trifluoperazine, 13.3 olanzapine, 21 clozapine and 31.3 quetiapine).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 4 due to psychotropic agents; 1 each for quetiapine, nefazodone, fluoxetine and venlafaxine).
Naharci MI, Karadurmus N, Demir O, Bozoglu E, Ak M, Doruk H. (2011). Fatal hepatotoxicity in an elderly patient receiving low-dose quetiapine. Am J Psychiatry. (77 year old woman developed fatigue and jaundice 9 days after starting quetiapine [bilirubin 4.8 mg/dL, ALT 1565 U/L, Alk P 178 U/L, INR 4.1], with subsequent multiorgan failure and death, despite improvement in liver tests).
Al Mutairi F, Dwivedi G, Al Ameel T. (2012). Fulminant hepatic failure in association with quetiapine: a case report. J Med Case Rep. (59 year old woman developed weakness 3 weeks and jaundice 6 weeks after starting quetiapine [bilirubin 14.3 mg/dL, ALT 711 U/L, Alk P 196 U/L, INR 2.7], with signs of hepatic failure, but ultimate slow recovery after stopping).
Lin CH, Liu CM, Huang WL. (2012). Quetiapine-induced hepatocellular damage. Psychosomatics. (47 year old woman developed serum enzyme elevations within 3 weeks of starting quetiapine for schizophrenia [bilirubin 0.4 mg/dL, ALT 113 U/L, Alk P 547 U/L], having been normal shortly before and returning to normal within 2 weeks of decreasing the dose [from 400 to 300 mg daily] and recurring when high doses were restarted).
Sistanizad M, Peterson GM. (2013). Drug-induced liver injury in the Australian setting. J Clin Pharm Ther. (Among 17 cases of suspected drug induced liver injury seen at a single referral hospital in Tasmania over a 12 month period, one was attributed to quetiapine occurring in a 63 year old woman with a mixed pattern of liver injury [peak ALT 467 U/L, Alk P 265 U/L] and judged as only "possibly" due to the drug).
Greil W, Häberle A, Schuhmann T, Grohmann R, Baumann P. (2013). Age and adverse drug reactions from psychopharmacological treatment: data from the AMSP drug surveillance programme in Switzerland. Swiss Med Wkly. (Among 39,728 patients treated with psychiatric medications in Swiss hospitals between 2001 and 2010 who were monitored in a drug surveillance program, rates of severe adverse events were similar in those above and below the age of 60 [1.6% vs 1.8%], although weight gain and ALT elevations were less frequent in the elderly [details not provided]).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to quetiapine or other atypical antipsychotic agents).
Brown ES, Davila D, Nakamura A, Carmody TJ, Rush AJ, Lo A, Holmes T, et al. (2014). A randomized, double-blind, placebo-controlled trial of quetiapine in patients with bipolar disorder, mixed or depressed phase, and alcohol dependence. Alcohol Clin Exp Res. (Among 90 patients with bipolar disorder with depression and alcohol dependence who were treated with quetiapine or placebo for 12 weeks, alcohol use was similar in the two groups; ALT levels were not mentioned, but there were no liver related serious adverse events).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to quetiapine or other atypical antipsychotic medications).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 3 of which were attributed to quetiapine).
Vatsalya V, Pandey A, Schwandt ML, Cave MC, Barve SS, Ramchandani VA, McClain CJ. (2016). Safety assessment of liver injury with quetiapine fumarate XR management in very heavy drinking alcohol-dependent patients. Clin Drug Investig. (Among 218 adults with alcohol dependence treated with quetiapine or placebo for 12 weeks, there was a moderate increase in the likelihood of having ALT elevations in quetiapine treated subjects with and without preexisting elevations, although the differences [not provided] were judged to be "not clinically significant in that they required no medical management").
Morlán-Coarasa MJ, Arias-Loste MT, Ortiz-García de la Foz V, Martínez-García O, Alonso-Martín C, Crespo J, Romero-Gómez M, et al. (2016). Incidence of non-alcoholic fatty liver disease and metabolic dysfunction in first episode schizophrenia and related psychotic disorders: a 3-year prospective randomized interventional study. Psychopharmacology (Berl). (Among 191 schizophrenic patients treated with an atypical antipsychotic agent for at least 3 years, surrogate markers for steatosis arose in 48 [25%], most of whom had a 7% increase in body weight [n=44: 92%], increase in triglycerides [54%], total cholesterol [52%], and waist circumference [68%]; changes in regard to fatty liver did not vary by specific antipsychotic agent [46 received quetiapine]).
Hayes JF, Marston L, Walters K, Geddes JR, King M, Osborn DP. (2016). Adverse renal, endocrine, hepatic, and metabolic events during maintenance mood stabilizer treatment for bipolar disorder. PLoS Med. (Analysis of UK electronic health data on patients with bipolar disorder between 1995 and 2013, found greater than 15% weight gain to be higher with valproate [Hazard Ratio: HR=1.6], olanzapine [HR=1.8], quetiapine [HR=1.7] compared to lithium alone).
(2016). Drugs for psychotic disorders. Med Lett Drugs Ther. (Concise review of medications available in the US for therapy of psychotic disorders; mentions that olanzapine can cause aminotransferase elevations, and that olanzapine and ziprasidone can cause DRESS syndrome, but does not mention ALT elevations or hepatotoxicity for any of agents discussed, including aripiprazole, brexpiprazole, cariprazine, clozapine, quetiapine, risperidone, asenapine, iloperidone, paliperidone and lurasidone).
Das A, Guarda LA, Allen LG. (2017). Liver injury associated with quetiapine: an illustrative case report. J Clin Psychopharmacol. (45 year old woman developed jaundice a year after starting and 3 weeks after increasing the dose of quetiapine [bilirubin 18.2 mg/dL, ALT 95 U/L, Alk P 267 U/L, INR 1.45], which improved on stopping, but documentation not provided).
Baeza I, de la Serna E, Calvo-Escalona R, Merchán-Naranjo J, Rodríguez-Latorre P, Martínez-Cantarero MC, Andrés P, et al. (2018). One-year prospective study of liver function tests in children and adolescents on second-generation antipsychotics: is there a link with metabolic syndrome?. J Child Adolesc Psychopharmacol. (Among 216 children and adolescents starting atypical antipsychotics, mean weight gain at 6 months was 6.5 kg and mean ALT levels increased by 8.6 U/L, while among 19 taking quetiapine for 6 months mean weight gain was 10.3 kg and ALT increase 42.5 U/L; increases in ALT associated most closely with development of the metabolic syndrome, mean ALT increasing by 27.8 U/L at 6 months).
Druschky K, Toto S, Bleich S, Baumgärtner J, Engel RR, Grohmann R, Maier HB, et al. (2021). Severe drug-induced liver injury in patients under treatment with antipsychotic drugs: data from the AMSP study. World J Biol Psychiatry. (Among 246 cases of severe liver injury due to antipsychotic medications identified in a prospective registry of German psychiatric hospitals between 1993 and 2016, 46 arose in 38,349 patients [0.12%] who received clozapine [34 as a single antipsychotic agent]; other commonly implicated agents being olanzapine [n=90 of 54,822: 0.16%], quetiapine [34 of 66,209: 0.05%] and risperidone [27 of 51,683: 0.05%]; two fatal cases occurred in olanzapine-treated patients).
Zeiss R, Hafner S, Schönfeldt-Lecuona C, Connemann BJ, Gahr M. (2022). Drug-associated liver injury related to antipsychotics: exploratory analysis of pharmacovigilance data. J Clin Psychopharmacol. (Review of the VigiBase data base of individual case safety reports on antipsychotics and liver injury found positive hepatic safety signals for olanzapine and clozapine, but none for risperidone, quetiapine, ziprasidone, asenapine, aripiprazole, brexpiprazole, and cariprazine).
Gunther M, Dopheide JA. (2023). Antipsychotic safety in liver disease: a narrative review and practical guide for the clinician. J Acad Consult Liaison Psychiatry. (Review of the literature on hepatotoxicity of antipsychotic medications and guidance on their use in patients with liver disease characterizes chlorpromazine, clozapine, and olanzapine as having the greatest risk for causing liver injury, quetiapine and risperidone as having moderate risk, haloperidol as having low risk and paliperidone, aripiprazole, lurasidone, and loxapine as having low risk).

## OTHER REFERENCE LINKS

1 Recent References on Quetiapine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Quetiapine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Quetiapine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Quetiapine)